# Alefacept

## OVERVIEW

### Introduction

Alefacept is a recombinant fusion protein of lymphocyte function associated antigen-3 (LFA-3) and immunoglobulin G dimer that acts to block the activation of T cells, and is an immunosuppressive agent that was previously used to treat moderate-to-severe plaque psoriasis. Alefacept is associated with a low rate of serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Alefacept (a lef' a sept) is a recombinant fusion protein that combines the lymphocyte function associated antigen-3 (LFA3) with the heavy chain of immunoglobulin G. The fusion protein inhibits the binding of endogenous LFA3 to CD2 cells interfering with activation of memory T cells which play an important role in the pathogenesis of inflammatory autoimmune diseases. In controlled clinical trials, alefacept therapy improved symptoms and skin lesions in patients with refractory psoriasis. Alefacept was approved for use in the United States in 2003 and was the first biological agent approved for treatment of psoriasis. However, because of the availability of better tolerated and more effective biologics for psoriasis, alefacept was withdrawn from use by its sponsor in 2011. Alefacept had been available as a solution for parenteral administration in single use vials of 7.5 or 15 mg under the brand name Amevive. Alefacept was given once weekly, either intramuscularly in a dose of 15 mg or intravenously in a dose of 7.5 mg for 12 weeks. Repeat courses were recommended for patients who responded to therapy and then relapsed. Alefacept also showed activity in treatment and prevention of graft rejection after transplantation but was never approved for that use. Common side effects included headache, dizziness, nausea, myalgias, injection site reactions and infections. Rare, but potentially severe adverse reactions included lymphopenia, serious infections, hypersensitivity reactions and an increased risk for malignancy.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT or AST elevations greater than 3 times the upper limit of normal (ULN) occurred in <2% of alefacept and a similar proportion of placebo treated subjects. The elevations were usually mild-to-moderate in severity, asymptomatic and self-limited in course. ALT elevations accompanied by jaundice and symptoms were not reported in the premarketing studies. Subsequent to its approval and more wide scale use, however, cases of marked serum enzyme elevations, acute hepatitis and acute liver failure have been reported to the sponsor. These cases have not been reported in the literature and the strength of the association of these episodes with alefacept use has not been evaluated critically. The clinical features, characteristics, course and outcome of these episodes of hepatitis have not been described.

Likelihood score: E* (unproven but suspected rare cause of liver injury).

### Mechanism of Injury

The mechanism of possible liver injury due to alefacept is unknown. Alefacept is a recombinant protein and unlikely to have intrinsic hepatotoxicity. However, because it is a potent immunomodulatory agent, it may be capable of causing reactivation of hepatitis B or autoimmune liver injury.

### Outcome and Management

Liver injury attributed to alefacept has ranged from uncommon instances of transient serum enzyme elevations without symptoms or jaundice to rare cases of acute clinically apparent liver injury.

Drug Class: Dermatologic Agents, Psoriasis Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alefacept – Amevive®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Alefacept)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alefacept | 222535-22-0 | Recombinant Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 September 2021

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Ellis CN, Krueger GG, Alefacept Clinical Study Group. (2001). Treatment of chronic plaque psoriasis by selective targeting of memory effector T lymphocytes. N Engl J Med. (Among 229 patients with psoriasis treated with various doses of intravenous alefacept or placebo weekly for 12 weeks, clinical responses occurred in 38-53% of alefacept vs 21% of placebo recipients, adverse events were generally mild and "laboratory tests showed no significant changes in serum chemical... values in any study groups").
Krueger GG, Papp KA, Stough DB, Loven KH, Gulliver WP, Ellis CN, Alefacept Clinical Study Group. (2002). A randomized, double-blind, placebo-controlled phase III study evaluating efficacy and tolerability of 2 courses of alefacept in patients with chronic plaque psoriasis. J Am Acad Dermatol. (Abstract; among 553 patients with chronic plaque psoriasis treated with two 12 week courses of one weekly alefacept or placebo, clinical responses occurred in 28% of alefacept vs 8% of placebo treated subjects and side effects were mild; no mention of ALT elevations or hepatotoxicity).
Ortonne JP. (2003). Clinical response to alefacept: results of a phase 3 study of intramuscular administration of alefacept in patients with chronic plaque psoriasis. J Eur Acad Dermatol Venereol. (Among 507 patients with psoriasis treated with 10 or 15 mg per week of alefacept or placebo for 12 weeks, clinical responses occurred in 12% and 21% of alefacept vs 5% of placebo recipients, and "minor elevations in serum aminotransferase levels were noted in all 3 groups", but there were no hepatic severe adverse events).
(2003). Alefacept (Amevive) for treatment of psoriasis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, efficacy, safety and cost of alefacept shortly after its approval for use in psoriasis in the US, does not mention ALT elevations or liver injury as side effects).
Goffe B, Papp K, Gratton D, Krueger GG, Darif M, Lee S, Bozic C, et al. (2005). An integrated analysis of thirteen trials summarizing the long-term safety of alefacept in psoriasis patients who have received up to nine courses of therapy. Clin Ther. (In a pooled analysis of adverse events from 13 controlled trials of alefacept which enrolled 1869 patients with psoriasis, common side effects were headache and nasopharyngitis and pruritus, but were rarely severe or required discontinuation and there were "no clinically relevant trends with respect to changes from baseline in laboratory parameters"; no mention of ALT elevations or hepatotoxicity).
Scheinfeld N. (2005). Alefacept: a safety profile. Expert Opin Drug Saf. (Review of clinical trials of alefacept mentions that ALT elevations have occurred on treatment "but do not appear to be clinically significant" and that cases of hepatitis with jaundice have been reported; in clinical trials in more than 2000 patients, there have been no cases of exacerbation of hepatitis B or C).
Thaçi D, Pätzold S, Kaufmann R, Boehncke WH. (2005). Treatment of psoriasis with alefacept in patients with hepatitis C infection: a report of two cases. Br J Dermatol. (Two men, ages 29 and 63 years, with chronic hepatitis C and psoriasis were treated with weekly injections of alefacept for 12 weeks and had no worsening in serum ALT or HCV RNA levels or other adverse reaction).
Mease PJ, Gladman DD, Keystone EC, Alefacept in Psoriatic Arthritis Study Group. (2006). Alefacept in combination with methotrexate for the treatment of psoriatic arthritis: results of a randomized, double-blind, placebo-controlled study. Arthritis Rheum. (Among 146 patients with psoriatic arthritis and normal liver tests in a 12 week controlled trial, 1 of 93 treated with alefacept and methotrexate vs 1 of 59 on methotrexate alone developed ALT elevations above 3 times ULN, but both patients recovered without intervention or stopping therapy).
Perlmutter A, Cather J, Franks B, Jaracz E, Menter A. (2008). Alefacept revisited: Our 3-year clinical experience in 200 patients with chronic plaque psoriasis. J Am Acad Dermatol. (Analysis of 201 patients with psoriasis treated with alefacept in a total of 296 courses, therapy was stopped early in one patient who was also on methotrexate because of serum enzyme elevations, but no details provided).
Castelo-Soccio L, Van Voorhees AS. (2009). Long-term efficacy of biologics in dermatology. Dermatol Ther. (Review of long term efficacy of various biologics used to treat psoriasis, including alefacept and the anti-tumor necrosis factor agents; no discussion of hepatotoxicity).
Mease PJ, Reich K, Alefacept in Psoriatic Arthritis Study Group. (2009). Alefacept with methotrexate for treatment of psoriatic arthritis: open-label extension of a randomized, double-blind, placebo-controlled study. J Am Acad Dermatol. (Among 160 patients who enrolled in an extension phase study of alefacept for psoriatic arthritis, increased AST levels [1-3 times ULN] occurred in 30% of patients, but were above 3 times ULN in only 2% during the open-label extension phase).
Ahn CS, Gustafson CJ, Sandoval LF, Davis SA, Feldman SR. (2013). Cost effectiveness of biologic therapies for plaque psoriasis. Am J Clin Dermatol. (In a systematic review and assessment of five biologic agents approved for use in the therapy of psoriasis [adalimumab, etanercept, infliximab, ustekinumab, and alefacept], alefacept was found to be the least cost effective).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to alefacept).
Rønholt K, Iversen L. (2017). Old and new biological therapies for psoriasis. Int J Mol Sci. (Review of biologics used to treat psoriasis; alefacept was the first biologic approved for use in psoriasis in the US, but was withdrawn because of relative lack of efficacy compared to other biologics).

## OTHER REFERENCE LINKS

1 Recent References on Alefacept: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Alefacept+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Alefacept: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alefacept)